# Losartan

## OVERVIEW

### Introduction

Losartan is an angiotensin II receptor blocker used in the therapy of hypertension and diabetic nephropathy. Losartan is associated with a low rate of transient serum aminotransferase elevations and has been linked to rare instances of acute liver injury.

### Background

Losartan (loe sar' tan) was the first angiotensin II receptor blocker (ARB) to be approved for use in the United States and is still widely used for therapy of hypertension. Losartan inhibits the renin-angiotensin system by blocking the angiotensin II type 1 receptor (AT1), which prevents the vasoconstriction and volume expansion induced by circulating angiotensin II and thus accounts for its antihypertensive activity. Losartan was approved for use in the United States in 1995 and current indications include hypertension as well as prevention of progression of diabetic nephropathy, and decrease in risk of stroke in patients with hypertension and left ventricular hypertrophy. Losartan is available in 25, 50 and 100 mg tablets in generic forms and under the trade name Cozaar. Fixed dose combinations with hydrochlorothiazide are also available (Hyzaar and others). The typical dose of losartan in adults in 50 to 100 mg in one or two divided doses daily and it is used long term. Side effects are uncommon, but can include headache, dizziness, fatigue, cough, gastrointestinal upset, and fetal toxicity. Chronic therapy with losartan has been implicated in rare instances of severe sprue-like enteropathy that typically presents after months or years of therapy with diarrhea, weight loss, and abdominal discomfort. Intestinal biopsy that shows villous fattening and atrophy, similar to celiac disease. However, the diarrhea does not improve with a gluten-free diet, but does resolve promptly with stopping the losartan. This adverse effect is most common with olmesartan.

### Hepatotoxicity

Losartan has been associated with a low rate of serum aminotransferase elevations (<2%) that in controlled trials was no higher than with placebo therapy. These elevations were transient and rarely required dose modification. Rare instances of clinically apparent acute liver injury have been reported in association with losartan therapy. The onset is usually within 1 to 8 weeks of starting therapy and the serum enzyme pattern is typically hepatocellular with an acute hepatitis-like clinical syndrome. In some instances, cholestasis has developed which can be prolonged and relapsing, but losartan therapy has not been associated with vanishing bile duct syndrome or chronic liver injury. Immunoallergic manifestations (rash, fever, eosinophilia) are not common, nor is autoantibody formation. serum aminotransferase levels may also be raised in patients who develop angiotensin receptor antagonist-related enteropathy caused by fatty liver and steatohepatitis due to the diarrhea and malnutrition.

Likelihood score: C (Probable cause of rare instances of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations and the acute liver injury associated with losartan is not known, but resembles idiosyncratic liver injury due to a hypersensitivity reaction. Losartan is metabolized by the liver via the cytochrome P450 system, predominantly by CYP 2C9 and 3A4.

### Outcome and Management

The instances of acute liver injury reported with losartan use have been self limited and have not resulted in acute liver failure or chronic liver injury. While corticosteroids have been used in cases of severe cholestasis due to losartan, their efficacy has not been shown and their use is best avoided. Patients with losartan induced acute liver injury should probably avoid use of other ARBs, although cross sensitivity to liver injury among the members of this class of agents has not been shown.

References on the safety and potential hepatotoxicity of losartan are given in the Overview section on the angiotensin II receptor antagonists.

Drug Class: Antihypertensive Agents, Angiotensin II Receptor Antagonists

Other Drugs in the Subclass, Angiotensin II Receptor Antagonists: Azilsartan, Candesartan, Eprosartan, Irbesartan, Olmesartan, Telmisartan, Valsartan

## CASE REPORT

### Case 1. Acute hepatitis due to losartan.

[Modified from: Bosch X. Losartan-induced hepatotoxicity. JAMA 1997; 278: 1572. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/9370501)]

A 46 year old man developed fatigue, anorexia, nausea and jaundice two weeks after switching from enalapril (10 mg daily for 3 months) to losartan (50 mg daily) as therapy for his essential hypertension. He had no history of liver disease, jaundice, excessive alcohol use, risk factors for viral hepatitis or previous serious drug reactions. Four weeks after starting losartan and after two weeks of symptoms, examination showed that he was jaundiced, had a low grade fever (37.7 oC) and mild hepatic tenderness. Laboratory tests revealed moderate elevations in serum bilirubin (9.6 mg/dL) with marked elevations in serum aminotransferase levels (ALT 2574 U/L, AST 2042 U/L) and alkaline phosphatase (738 U/L) (Table). There was no eosinophilia. Tests for hepatitis A, B and C were negative as were autoantibodies. Ultrasound of the liver showed hepatomegaly without evidence of biliary obstruction. Losartan was stopped on admission, and atenolol was substituted. He improved rapidly and four months later he was asymptomatic and all liver tests were normal. At that point he was rechallenged with losartan (25 mg daily). Three weeks later jaundice and symptoms reappeared and losartan was stopped again. Six weeks later his liver tests were again normal.

#### Key Points

Medication: | Losartan (50 mg daily)
Pattern: | Hepatocellular (R=10)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 weeks
Recovery: | 4-12 weeks
Other medications: | Enalapril until 2 weeks before onset of symptoms

#### Laboratory Values

Weeks After Starting | Weeks After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Normal | Normal | Normal | Losartan started
4 | 0 | 2574 | 738 | 9.6 | Losartan stopped
8 | 4 | 218 | | 2.3
20 (0)* | 16 | 32 | | 0.7 | Losartan restarted
23 (3) | 19 (0) | 254 | | 4.2 | Losartan stopped
29 (9) | 25 (6) | Normal | Normal | Normal
Normal Values | | <40 | <115 | <1.2

*Values in parenthesis represent weeks after restarting losartan.

#### Comment

The patient developed an acute hepatitis-like syndrome starting 2 weeks after switching his antihypertensive medications from enalapril to losartan. No other cause for the hepatitis was found and he recovered rapidly upon stopping losartan. The patient agreed to be rechallenged with a lower dose of losartan and a mild hepatitis arose 3 weeks later, making this a very convincing case of losartan-associated acute hepatitis.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Losartan – Cozaar®

DRUG CLASS

Angiotensin II Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Losartan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Losartan | 124750-99-8 | C22-H23-Cl-N6-O.K | Chemical Structure for Losartan

## OTHER REFERENCE LINKS

1. Recent References on Losartan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Losartan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Losartan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Losartan)